# Metformin

## OVERVIEW

### Introduction

Metformin is a first line agent for the treatment of type 2 diabetes that can be used alone or in combination with sulfonylureas, thiazolidinediones, incretin-based drugs, sodium glucose cotransporter-2 inhibitors, or other hypoglycemic agents. Metformin has not been linked to serum enzyme elevations during therapy and is an exceeding rare cause of idiosyncratic clinically apparent acute liver injury.

### Background

Metformin (met for' min) is a biguanine and acts as an insulin sensitizing agent, probably through activation of adenosine monophosphate dependent (AMP) kinase in liver and muscle tissue. Metformin is often associated with weight loss making it a preferred, first line agent for management of overweight patients with type 2 diabetes. Initial concerns about the possibility that metformin (like the related biguanine phenformin) could induce lactic acidosis have been largely resolved, although the agent is contraindicated in patients with renal dysfunction because of this reason and should be used with caution in patients with significant liver disease. Metformin was approved for use in the United States in 1995 and is currently one of the most commonly used drugs for the therapy of diabetes, with more than 30 million prescriptions filled in the United States yearly. Metformin is available in many generic forms in tablets of 500, 850 or 1000 mg, the recommended regimen being to start with 500 or 850 mg once daily and increase based upon tolerance to 1000 to 2550 mg daily taken in two divided doses. Commercial formulations include Glucophage, Glumetza, Fortamet and Riomet. Metformin is also available in extended release formulations and in combinations with sulfonylureas such as glipizide (Metaglip) or glyburide (Glucovance), DDP-4 inhibitors such as alogliptin (Kazano), linagliptin (Jentadueto), saxagliptin (Kombiglyze) and sitagliptin (Janumet), as well as thiazolidinediones such as pioglitazone (Actoplus) and rosiglitazone (Avandamet). Metformin is generally well tolerated but side effects can include diarrhea, gastrointestinal upset, abdominal pain, nausea, metallic taste, weakness, headache, dizziness and rash. Rare but potentially severe adverse events include lactic acidosis, hypoglycemia, dehydration and hypersensitivity reactions.

### Hepatotoxicity

Minor enzyme elevations have been reported to occur during metformin therapy in less than 1% of patients. Indeed, metformin may actually lower elevated aminotransferase levels in patients with fatty liver disease. Clinically apparent liver injury from metformin is very rare, fewer than a dozen cases having been described in the literature despite widespread use of this agent for several decades. The liver injury usually appears after 1 to 8 weeks, typically with symptoms of weakness and fatigue followed by jaundice. Various combinations of hepatocellular and cholestatic injury have been described, and many have been mixed. Allergic manifestations are not typical but rash, fever and eosinophilia have been described. Autoantibody formation is also not typical. Because this agent is usually given in combination with other hypoglycemic agents, many of which also cause liver injury, it can be difficult to establish whether the injury is due to metformin or another agent. The timing of injury is perhaps most characteristic, the injury arising soon after the agent is started and not during long term therapy. Recovery is usually rapid after metformin is stopped.

Likelihood score: B (rare but well documented cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to metformin is unknown. Metformin may actually be beneficial for some forms of liver disease, such as nonalcoholic steatohepatitis and need not be avoided in patients with mild, preexisting serum enzyme abnormalities. Acute liver injury from metformin may have a metabolic basis, arising after weeks to months of therapy. Rechallenge can lead to recurrence, but also requires weeks to months of therapy before injury reappears.

### Outcome and Management

The liver injury from metformin usually resolves rapidly once the agent is stopped. Chronic injury has not been described. No convincing cases of fulminant hepatic failure from metformin have been reported. In cases in which multiple hypoglycemic agents were being used when the liver injury appears, rechallenge with the agent least likely associated with the injury is appropriate. There is no cross reactivity in hepatotoxicity with other antidiabetic medications.

Drug Class: Antidiabetic Agents

## CASE REPORTS

### Case 1. Acute hepatitis due to metformin.(1)

A 67 year old woman with diabetes was started on metformin (500 mg twice daily) and developed fatigue, weakness and jaundice five weeks later. She had no history of liver disease or risk factors for viral hepatitis and did not drink alcohol. She had coronary artery disease and medications taken chronically included aspirin, isosorbide mononitrate, diltiazem and acarbose. On admission, 6 weeks after starting metformin, she had a total bilirubin of 4.8 mg/dL (Table). Tests for hepatitis A, B and C were negative. She had antinuclear antibodies (1:320). An abdominal ultrasound and CT scan were normal. Liver biopsy showed acute inflammation. Metformin and acarbose were withdrawn and gliclazide started. The jaundice slowly resolved over the next three months, but metformin was subsequently restarted, and jaundice reappeared 3 months later. Metformin was again withdrawn and her liver injury improved slowly.

#### Key Points

Medication: | Metformin (500 mg twice daily)
Pattern: | Hepatocellular (R=26)
Severity: | 3+ (hospitalization for jaundice)
Latency: | 5 weeks
Recovery: | Complete within 2 months
Other medications: | Acarbose, diltiazem, aspirin, isosorbide mononitrate

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
6 weeks | 0 | 905 | 121 | 4.8 | ANA: 1:320
7 weeks | 1 week | 960 | | 4.5 | Liver biopsy
8 weeks | 2 weeks | 1160 | | 3.0
9 weeks | 3 weeks | 1080 | | 3.0
3 months | 6 weeks | 280 | | 4.0
4 months | 10 weeks | 120
| 12 weeks | 40 | | 1.0
Metformin restarted approximately 4 months later
12 weeks | 0 | 880 | | 3.0
13 weeks | 1 week | 1240 | | 2.5 | ANA still present
14 weeks | 2 | 1120 | | 2.2
15 weeks | 3 | 920 | | 2.1
4 months | 4 | 800 | | 2.5
5 months | 9 | 480 | | 1.0
6 months | 13 | 40 | | 1.0
Normal Values | | <40 | <130 | <1.2

* Values of ALT and bilirubin were estimated from the figure and converted from times upper limit of normal to absolute values based upon normal values provided.

#### Comment

This patient developed an acute hepatitis-like illness with mild jaundice after 5 weeks of therapy with metformin which was somewhat slow to resolve. Upon rechallenge, there was a recurrence of the liver injury, but only after metformin had been given for several months. Nevertheless, the pattern and subsequent course of the liver injury was similar to the original episode making it likely that metformin was the cause of the injury. While most causes of liver injury were excluded (hepatitis A, B and C, cholecystitis), the presence of a strongly positive ANA raises the possibility that the patient had autoimmune hepatitis with an acute, fluctuating onset and course. The liver biopsy apparently did not suggest autoimmune hepatitis, but this possibility can be excluded only by further follow up. In assessing hepatotoxicity from commonly used medications such as metformin, the possibility of an unusual presentation of a common liver disease must always be considered.

### Case 2. Acute hepatitis-like injury due to metformin.(2)

A 73 year old Japanese woman with poorly controlled diabetes, despite therapy with a sulfonylurea and pioglitazone, was started on metformin (500 mg twice daily) and developed fatigue, weakness and jaundice 3 weeks later. She was known to have had normal liver tests before starting metformin. On admission, laboratory testing showed a total bilirubin of 6.5 mg/dL and a hepatocellular pattern of serum enzyme elevations (Table). All oral antidiabetic agents were stopped and she was managed on insulin. Tests for hepatitis B and C infection were negative as were autoantibodies. Ultrasound, CT and ERCP were unremarkable. Her serum enzymes improved rapidly once metformin was stopped and were normal 7 weeks later.

#### Key Points

Medication: | Metformin (500 mg twice daily)
Pattern: | Hepatocellular (R=21)
Severity: | 3+ (hospitalization for jaundice)
Latency: | 3 weeks
Recovery: | Complete within 2 months
Other medications: | Nateglinide and pioglitazone for 6 months

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 16 | 337 | 0.7
3 weeks | 0 | 772 | 635 | 6.5 | Admission
4 weeks | 1 weeks | 353 | 480 | 3.2
6 weeks | 3 weeks | 101 | | 2.6 | Symptoms resolved
8 weeks | 5 weeks | 65 | | 1.7
10 weeks | 7 weeks | 13 | | 0.6
Normal Values | | <36 | <359 | <1.2

#### Comment

The patient developed an acute hepatitis-like illness with mild jaundice 3 weeks after metformin was added to a chronic regimen of a metiglinide analogue and thiazolidinedione for poorly controlled diabetes. Symptoms resolved within 2 weeks and all liver tests were normal 7 weeks after stopping the medications. No other cause for acute hepatitis was identified. Both nateglinide and pioglitazone have been reported to cause liver injury, but the timing of onset of the hepatitis most closely implicates metformin. Rechallenge with the other antidiabetic medications would have been appropriate.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Metformin – Generic, Fortamet®, Glucophage®, Riomet®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Metformin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Metformin | 657-24-9 | C4-H11-N5

## CITED REFERENCES

1 Deutsch M, Kountouras D, Dourakis SP. (2004). Metformin hepatotoxicity. Ann Intern Med.
2 Kutoh E. (2005). Possible metformin-induced hepatotoxicity. Am J Geriatr Pharmacother.

## ANNOTATED BIBLIOGRAPHY

References updated: 21 January 2020

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 578. (Expert review of biguanides and liver injury published in 1999 which mentions that metformin, despite use for several years, had not been implicated in causing hepatic injury).
De Marzio DH, Navarro VJ. Biguanides. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 531. (Review of hepatotoxicity of drugs for diabetes metions that metformin can cause either a cholestatic or hepatocellular pattern of liver injury, with latency of 1 to 8 weeks, and which resolve rapidly when metformin is stopped, no fatal cases having been described).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BAHillal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 870-83. (Textbook of pharmacology and therapeutics).
Cubukcu A, Yilmaz MT, Satman I, Buyukdevrim AS. (1991). Metformin kullanimina bagli bir akut hepatiti vakasi (metformin-induced hepatitis). Tip Fak Mecm. (57 year old woman developed jaundice 4 weeks after starting metformin [bilirubin 4.3 mg/dL, ALT 453, Alk P ~2x ULN], resolving within 4 weeks of stopping).
Bailey CJ, Turner RC. (1996). Metformin. N Engl J Med. (Clinical review of pharmacokinetics, mechanism of action, efficacy and safety of metformin as therapy of type 2 diabetes; no mention of hepatotoxicity).
Babich MM, Pike I, Shiffman ML. (1998). Metformin-induced acute hepatitis. Am J Med. (52 year old woman developed fatigue after 3 weeks of metformin therapy, followed by jaundice [bilirubin 14.4 mg/dL, ALT 651 U/L, Alk P 500 U/L], with resolution within a month of stopping).
Lin KD, Lin JD, Juang JH. (1998). Metformin-induced hemolysis with jaundice. N Engl J Med. (46 year old man became jaundiced within 2 weeks of starting metformin, with normal ALT and evidence of hemolysis; jaundice reappeared with rechallenge).
Swislocki AL, Noth R. (1998). Case report. Pseudohepatotoxicity of metformin. Diabetes Care. (75 year old man with Paget's disease and diabetes developed elevations in serum ALT [33 to 413 U/L] and AST [36 to 322 U/L] and worsening Alk P [470 to 684 U/L], without symptoms or jaundice after 2 months of metformin therapy; rechallenge for 1 month was not followed by recurrence; authors concluded that this represented "pseudohepatotoxicity").
Crespo Valadés E, Ortega Gómez A, Alvarado Izquierdo MI, Magro Ledesma D. [Hepatotoxic reaction associated with metformin and chlorpropamide treatment] Rev Clin Esp 1999; 199: 118-9. Spanish. PMID: 10216414 (68 year old mother developed an acute immunoallergic reaction 2 days after starting metformin with fever, eosinophilia, rash and lymphadenopathy accompanied by a mild cholestatic hepatitis [bilirubin 2.2 mg/dL, ALT 327 U/L, Alk P 2553 U/L], rapidly resolving upon stopping therapy).
Chaudhry MU, Simmons DL. (2001). Case of the month. Hepatic and renal failure in a patient taking troglitazone and metformin. J Ark Med Soc. (54 year old man developed jaundice after 5 years of metformin and 2 years of troglitazone after episode of bloody diarrhea and hypotension [bilirubin 17 mg/dL, ALT 574 U/L, Alk P 125 U/L], resolving after stopping oral agents and stabilization of heart disease).
Desilets DJ, Shorr AF, Moran KA, Holtzmuller KC. (2001). Cholestatic jaundice associated with the use of metformin. Am J Gastroenterol. (64 year old man developed fatigue and jaundice 2 weeks after starting metformin [bilirubin 21.3 mg/dL, ALT 289 U/L, Alk P 994 U/L], resolving within 3 months of stopping).
Lebovitz HE, Kreider M, Freed MI. (2002). Evaluation of liver function in type 2 diabetic patients during clinical trials: evidence that rosiglitazone does not cause hepatic dysfunction. Diabetes Care. (Analysis of more than 6000 patients in industry sponsored clinical trials found ALT levels >3 times ULN in 1.9% of troglitazone, 0.32% of rosiglitazone, 0.26% of pioglitazone, 0.40% of sulfonylurea and metformin, vs 0.17% of placebo treated patients; no mention of severe liver toxicity or jaundice).
Nammour FE, Fayad NF, Peikin SR. (2003). Metformin-induced cholestatic hepatitis. Endocr Pract. (68 year old man developed severe jaundice 4 weeks after starting metformin [bilirubin 15.7 mg/dL, ALT 109 U/L, Alk P 383 U/L], biopsy showed severe cholestasis, slow recovery and Alk P still elevated 3 months later).
Deutsch M, Kountouras D, Dourakis SP. (2004). Metformin hepatotoxicity. Ann Intern Med. (67 year old woman developed jaundice 5 weeks after starting metformin [bilirubin 4.8 mg/dL; ALT 905 U/L; Alk P 121 U/L], resolving within 2 months of stopping and recurring 3 months after restarting: Case 1).
Barquero Romero J, Pérez Miranda M. [Metformin-induced cholestatic hepatitis] Gastroenterol Hepatol 2005; 28: 257-8. Spanish. PMID: 15811270 (80 year old woman developed jaundice ~10 weeks after starting metformin [bilirubin 5.3 mg/dL, ALT 174 U/L, Alk P 199 U/L], resolving within 2 months of stopping).
Kutoh E. (2005). Possible metformin-induced hepatotoxicity. Am J Geriatr Pharmacother. (73 year old woman developed jaundice 3 weeks after addition of metformin to chronic therapy with nateglinide and pioglitazone [bilirubin 6.5 mg/dL, ALT 772 U/L, Alk P 635 U/L], resolving within 7 weeks of stopping: Case 2).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, no single agent case was attributed to metformin).
de la Poza Gómez G, Rivero Fernández M, Vázquez Romero M, Angueira Lapeña T, Arranz de la Mata G, Boixeda de Miquel D. [Constitutional syndrome associated to metformin induced hepatotoxicity]. Gastroenterol Hepatol 2008; 31: 643-5. Spanish. PMID: 19174081 (83 year old man developed fatigue, weakness and weight loss several weeks after starting metformin [bilirubin 2.3 mg/dL, ALT 740 U/L, Alk P 586 U/L]; symptoms resolved within 2 weeks and liver tests fell to normal within 3 months of stopping).
Seidowsky A, Nseir S, Houdret N, Fourrier F. (2009). Metformin-associated lactic acidosis: a prognostic and therapeutic study. Crit Care Med. (Among 42 patients with voluntary or inadvertent metformin overdose, most had lactic acidosis, 50% circulatory shock, 74% renal failure, 33% died; factors correlating with survival were lactate levels, pH, creatinine and prothrombin time).
Olivera-González S, de Escalante-Yangüela B, Velilla-Soriano C, Amores-Arriaga B, Martín-Fortea P, Navarro-Aguilar ME. [Metformin-associated hepatotoxicity.]. Med Intensiva 2010; 34: 483-7. Spanish. PMID: 20045581 (73 year old woman with diabetes and heart disease developed weakness and abdominal pain 2 weeks after starting metformin [bilirubin 1.4 mg/dL, ALT 1294 U/L, Alk P 95 U/L, LDH 4957 U/L, lactate 6.9 mmol/L, INR 7.4] resolving within 2 weeks of stopping metformin).
Cone CJ, Bachyrycz AM, Murata GH. (2010). Hepatotoxicity associated with metformin therapy in treatment of type 2 diabetes mellitus with nonalcoholic fatty liver disease. Ann Pharmacother. (61 year old man with diabetes and fatty liver developed jaundice within 2 weeks of starting metformin [bilirubin 1.8 mg/dL, ALT 571 U/L, Alk P 143 U/L], resolving within 2 months of stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 4 were due to troglitazone but none to other antidiabetic medications).
Lavine JE, Schwimmer JB, Van Natta ML, Molleston JP, Murray KF, Rosenthal P, Abrams SH, Scheimann AO, et al., Nonalcoholic Steatohepatitis Clinical Research Network. (2011). Effect of vitamin E or metformin for treatment of nonalcoholic fatty liver disease in children and adolescents: the TONIC randomized controlled trial. JAMA. (Randomized controlled trial of metformin vs vitamin E vs placebo in 173 children with nonalcoholic fatty liver disease; serum aminotransferase levels fell in all three groups and no patient developed jaundice or evidence of hepatotoxicity).
(2011). Drugs for type 2 diabetes. Treat Guidel Med Lett. (Concise review of the role of antidiabetic medications in management of type 2 diabetes).
Arroyo D, Melero R, Panizo N, Goicoechea M, Rodríguez-Benítez P, Vinuesa SG, Verde E, et al. (2011). Metformin-associated acute kidney injury and lactic acidosis. Int J Nephrol. (Between 2006 and 2010, 29 patients presented with lactic acidosis and acute renal injury on metformin [duration not given], 10 of whom had underlying liver disease, which appeared to be a risk factor).
Miralles-Linares F, Puerta-Fernandez S, Bernal-Lopez MR, Tinahones FJ, Andrade RJ, Gomez-Huelgas R. (2012). Metformin-induced hepatotoxicity. Diabetes Care. (61 year old man developed jaundice 6 weeks after starting metformin [bilirubin 2.9 mg/dL, ALT 861 U/L, Alk P 622 U/L], resolving within 4 weeks of stopping and recurring within 24 hours of restarting [bilirubin 4.8 mg/dL, ALT 764 U/L, Alk P 622 U/L], resolving again within 4 weeks).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced lLiver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were due to metformin or other antidiabetic medications).
Zheng L. (2016). Metformin as a rare cause of drug-induced liver injury, a case report and literature review. Am J Ther. (70 year old woman developed nausea and abdominal pain 5 weeks after starting metformin [bilirubin 2.2 mg/dL, ALT 1093 U/L, Alk P 176 U/L], resolving within 14 days of stopping).
Saadi T, Waterman M, Yassin H, Baruch Y. (2013). Metformin-induced mixed hepatocellular and cholestatic hepatic injury: case report and literature review. Int J Gen Med. (78 year old man developed fatigue within a week of starting metformin, followed by jaundice [bilirubin 22.2 mg/dL, ALT 1050 U/L, Alk P 1001 U/L], resolving within 2 months of stopping; also received amoxicillin/clavulanate).
(2014). Drugs for type 2 diabetes. Treat Guidel Med Lett. (Concise recommendations on drugs for type 2 diabetes mentions that metformin is generally the preferred first line agent; side effects include metabllic taste, nausea, diarrhea, abdominal pain, and [in patients with impaired renal function] lactic acidosis; no mention of hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to metformin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 were attributed to antidiabetic medications, including 2 to metformin, one to sitagliptin and one to glibenclamide).
(2016). Metformin for prediabetes. Med Lett Drugs Ther. (Concise discussion of use of long term metformin to prevent diabetes in patients with elevated fasting and postprandial plasma glucose, discusses common adverse events but does not mention ALT elevations or hepatotoxicity).
Thalha AM, Mahadeva S, Boon Tan AT, Mun KS. (2018). Kombiglyze (metformin and saxagliptin)-induced hepatotoxicity in a patient with non-alcoholic fatty liver disease. JGH Open. (33 year old man with diabetes developed pruritus 1 week after starting the combination of metformin and saxagliptin [bilirubin 0.7 mg/dL, ALT 307 U/L, GGT 808 U/L], resolving within 2 months of stopping the combination agent and later tolerating, without worsening liver tests, the re-introduction of metformin suggesting that saxagliptin was the cause).
(2019). Drugs for type 2 diabetes. Med Lett Drugs Ther. (Concise recommendations on drugs for type 2 diabetes mentions that metformin is generally the drug of choice for initial treatment; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Metformin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(metformin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/12/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Metformin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=metformin)